# Osimertinib

## OVERVIEW

### Introduction

Osimertinib is a small molecule tyrosine kinase receptor inhibitor and antineoplastic agent that is used in the therapy of selected forms of advanced non-small cell lung cancer (NSCLC). Osimertinib is associated with a moderate rate of serum aminotransferase elevations during therapy and rare instances of clinically apparent acute liver injury.

### Background

Osimertinib (oh" sim er' ti nib) is a small molecule tyrosine kinase receptor inhibitor with potent activity against the epidermal growth factor receptor (EGFR) that is rearranged and mutated in selected cancers including approximately 5% of non-small cell lung cancer (NSCLC). The mutated, rearranged EGFR promotes unregulated cell growth and proliferation, and inhibition of its activity can result in death of cells that overexpress the receptor. Osimertinib has been found to inhibit mutated EGFR in cell culture and, in several clinical trials, was found to induce objective responses in a proportion of patients with advanced EGFR mutated (T790M) NSCLC. Osimertinib received accelerated approval for use refractory, EGFR T790M-positive NSCLC in the United States in 2015. Osimertinib is available in tablets of 40 and 80 mg under the brand name Tagrisso. The recommended initial dose is 80 mg once daily, continued until progressive disease or intolerable toxicity occurs. Side effects are common and include diarrhea, rash, dry skin and nail toxicity. Uncommon, but potentially severe side effects include interstitial lung disease, prolongation of the QTc interval, cardiomyopathy and embryo-fetal toxicity.

### Hepatotoxicity

Elevations in serum aminotransferase levels are uncommon during osimertinib therapy occurring in 4% to 5% of patients and rising above 5 times the upper limit of the normal range in only 1% or less. In preregistration trials, there was a single incidence of clinically apparent liver injury attributed to osimertinib therapy, but the clinical features and relatedness to therapy were not defined. Since its approval and more widespread use, there have been no published cases of liver injury due to osimertinib.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which osimertinib might cause liver injury is not known. Osimertinib is metabolized by the liver predominantly by CYP 3A4 and is susceptible to drug-drug interactions with agents that induce or inhibit FYP 3A4.

### Outcome and Management

Serum enzyme elevations during osimertinib therapy are uncommon, but elevations above 5 times the upper limit of normal (if confirmed) should lead to temporary discontinuation, which should be permanent if laboratory values do not improve significantly or resolve within a few weeks or if symptoms or jaundice arises. There does not appear to be cross reactivity with other EGFR inhibitors and, in some situations, switching to another protein kinase inhibitor may be appropriate.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Osimertinib – Tagrisso®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Osimertinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Osimertinib | 1421373-65-0 | Not available | Osimertinib structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 June 2017

Abbreviations used: NSCLC, non-small cell lung cancer; EGFR, epidermal growth factor receptor; ULN, upper limit of the normal range

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors such as osimertinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 2013 discusses the hepatotoxicity of crizotinib, but not osimertinib).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013; crizotinib is listed as causing liver enzyme elevations in up to 57% of patients [≥5 times ULN in 6%] and as having been linked cases of hepatitis and fatal hepatic failure; no mention of osimertinib). 23620168
Yang J, Ramalingam SS, Jänne PA, Cantarini M, Mitsudomi T. LBA2_PR: Osimertinib (AZD9291) in pre-treated pts with T790M-positive advanced NSCLC: updated Phase 1 (P1) and pooled Phase 2 (P2) results. J Thorac Oncol 2016; 11 (4 Suppl): S152-3. (Preliminary results in two trials of osimertinib in 474 patients with advanced NSCLC with T790M mutated EGFR revealed objective response rates of 66-71% and major side effects of rash and diarrhea).
Noonan SA, Sachs PB, Camidge DR. Transient asymptomatic pulmonary opacities occurring during osimertinib treatment. J Thorac Oncol 2016; 11: 2253-8. (Among 20 patients with NSCLC treated with osimertinib at a single referral center, 7 [35%] developed transient, asymptomatic pulmonary opacities [by CT scan], arising within 2-43 weeks of starting and resolving within 1-11 weeks despite continuation of osimertinib). 27618759
Goss G, Tsai CM, Shepherd FA, Bazhenova L, Lee JS, Chang GC, Crino L, et al. Osimertinib for pretreated EGFR Thr790Met-positive advanced non-small-cell lung cancer (AURA2): a multicentre, open-label, single-arm, phase 2 study. Lancet Oncol 2016; 17: 1643-52. (Among 199 patients with NSCLC with T790 mutant EGFR positivity treated with osimertinib [80 mg daily] with an average follow up of 13 months, 70% had an objective response and adverse events included ALT elevations in 5% of patients which were above 5 times ULN in 1%, one patient stopping therapy because of liver injury, no details provided). 27751847
Kotake M, Murakami H, Kenmotsu H, Naito T, Takahashi T. High incidence of interstitial lung disease following practical use of osimertinib in patients who had undergone immediate prior nivolumab therapy. Ann Oncol 2017; 28 (3): 669-70. (Among 19 Japanese patients with EGFR-T790M mutation-positive advanced NSCLC treated with osimertinib at a single Japanese institution, 4 developed interstitial lung disease within 4-12 weeks, 3 of whom had previously received nivolumab suggesting a synergistic effect in causing this adverse event; no mention of ALT elevations or liver injury). 27993813
Yang JC, Ahn MJ, Kim DW, Ramalingam SS, Sequist LV, Su WC, Kim SW, et al. Osimertinib in pretreated T790M-positive advanced non-small-cell lung cancer: AURA Study Phase II Extension Component. J Clin Oncol 2017; 35 (12): 1288-96. (Among 201 patients with NSCLC with T790M EGFR mutation treated with osimertinib, the objective response rate was 62% and many adverse events were described including diarrhea [43%], rash [40%], and interstitial lung disease [4%], but ALT elevations and hepatotoxicity were not mentioned). 28221867
Mok TS, Wu YL, Ahn MJ, Garassino MC, Kim HR, Ramalingam SS, Shepherd FA, He Y, et al.; AURA3 Investigators. Osimertinib or platinum-pemetrexed in EGFR T790M-positive lung cancer. N Engl J Med 2017; 376: 629-40. (Among 419 patients with refractory EGFR T790M-poisitive NSCLC treated with osimertinib vs platinum-pemetrexed chemotherapy, the objective response rate was greater with osimertinib [71% vs 31%] and serious adverse events were less frequent [23% vs 47%], including lower rates of ALT elevations [6% vs 11%] which were rarely above 5 times ULN [1% in both]). 27959700
Sun JM, Lee SH, Ahn JS, Park K, Ahn MJ. Osimertinib for the treatment of non-small cell lung cancer. Expert Opin Pharmacother 2017; 18: 225-31. (Review of the role of osimertinib in therapy of NSCLC, particularly in patients with the T790M mutation in EGFR which underlies resistance to first-generation tyrosine kinase inhibitors of EGFR; only brief mention of adverse events and no mention of ALT elevations or hepatotoxicity). 28116908
Mamesaya N, Kenmotsu H, Katsumata M, Nakajima T, Endo M, Takahashi T. Osimertinib-induced interstitial lung disease after treatment with anti-PD1 antibody. Invest New Drugs 2017; 35: 105-7. (38 year old woman with NSCLC and T790M mutation in EGFR received osimertinib shortly after a course of nivolumab [check point inhibitor] and developed interstitial lung disease after 31 days of treated, which improved upon stopping and worsened again on restarting osimertinib; no mention of ALT elevations or liver toxicity). 27599705

## OTHER REFERENCE LINKS

1. Recent References on Osimertinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Osimertinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Osimertinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Osimertinib)